# Tolvaptan

## OVERVIEW

### Introduction

Tolvaptan is a vasopressin 2 receptor antagonist which is used for short term treatment of severe hyponatremia in patients with heart failure, cirrhosis or syndrome of inappropriate secretion of antidiuretic hormone (SIADH). It has been used experimentally to prevention progression of disease in autosomal dominant polycystic kidney disease (ADPKD). Tolvaptan recently has been implicated in causing serum aminotransferase elevations as well as clinically apparent acute liver injury during long term use.

### Background

Tolvaptan (tol vap' tan) is a vasopressin 2 receptor antagonist (vaptan) that is used for treatment of hyponatremia caused by elevated levels of arginine vasopressin (also known as antidiuretic hormone: ADH), commonly found in patients with inappropriate ADH syndrome (SIADH) or with fluid overload from heart failure or cirrhosis. Vasopressin acts on type 2 receptors in the distal renal tubules causing reabsorption of free water, without electrolytes. Inappropriate secretion of vasopressin (as occurs in some paraneoplastic syndromes) is associated with retention of water and dilutional hyponatremia that can be symptomatic and even fatal. In controlled clinical trials, tolvaptan given for 28 days resulted in an increase in serum sodium and diuresis in patients with hypervolemic hyponatremia, in patients with cirrhosis and heart failure, and euvolemic hyponatremia in patients with SIADH. Tolvaptan was approved for use in the United States in 2009 and current indications are for short term therapy of patients with hypervolemic or euvolemic hyponatremia due to SIADH, congestive heart failure or cirrhosis. Tolvaptan has also been shown to prevent progression of disease in patients with autosomal dominant polycystic kidney disease (ADPKD), and was approved for this use in the United States in 2019. For therapy of hyponatremia, tolvaptan is available in tablets of 15 and 30 mg under the brand name Samsca. The recommended dose is 15 mg initially, titrating up to a maximum of 60 mg once daily, but limiting therapy to 30 days. For therapy of autosomal dominant polycystic kidney disease, tolvaptan is available in tablets of 15 and 30 mg under the brand name Jynarque and the recommended dose is 60 mg initially (given in two divided doses) and titrating carefully up to a maximum of 120 mg daily. Common side effects include excessive thirst, dry mouth and urinary frequency. Rare, but more serious side effects include hypernatremia and osmotic demyelination injury and acute liver injury.

### Hepatotoxicity

In prelicensure clinical trials, tolvaptan was not implicated in causing serum enzyme elevations or clinically apparent liver injury. However, instances of worsening of hepatic failure and complications of portal hypertension were reported in a small proportion of patients with cirrhosis treated with tolvaptan. These complications included variceal hemorrhage, hepatic encephalopathy and worsening of jaundice. In many trials, however, the frequency of these complications was not significantly greater than in placebo treated controls. More recently, in large registration trials of long term therapy in patients with ADPKD, serum aminotransferase elevations occurred in 4% to 5% of patients on tolvaptan, compared to only 1% of controls. Furthermore, clinically apparent liver injury occurred in approximately 0.1% of treated patients. The time to onset of illness ranged from 3 to 9 months (Case 1), but occasionally arose during long term therapy (Case 2). The clinical presentation was with the insidious development of fatigue, nausea and abdominal pain followed by dark urine, jaundice and pruritus. The pattern of serum enzyme elevations was typically hepatocellular or mixed, and liver biopsy showed an acute hepatitis with mild cholestasis. All patients recovered after stopping therapy, generally within 1 to 3 months of stopping therapy without evidence of residual injury. Immunoallergic features and autoantibodies were not found. Rapid recurrence on rechallenge was demonstrated in several patients with marked serum enzyme elevations during therapy, but patients with jaundice were not reexposed. The frequency of clinically apparent liver injury during therapy was one reason for the delay of formal approval of long term tolvaptan therapy for ADPKD. Since its approval and more wide-spread use, occasion reports of clinically apparent liver injury have continued to appear, at least one of which led to liver transplantation. Interestingly, most instances of liver injury have been reported with its use in autosomal dominant polycystic kidney disease rather than hyponatremia. Reasons for this are probably the duration of therapy, but also may relate to the slightly higher doses used to decrease progress in polycystic kidney disease.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

Tolvaptan is metabolized by the microsomal P450 drug metabolizing enzyme CYP 3A4 liver injury from tolvaptan may be due to activation of a toxic intermediate. Inhibitors of CYP 3A4 (such as ketoconazole) can raise levels of tolvaptan and should be avoided.

### Outcome and Management

The hepatic injury caused by tolvaptan is usually reversible with stopping the medication. Tolvaptan has not been linked to cases of acute liver failure, chronic hepatitis, prolonged cholestasis or vanishing bile duct syndrome. Rechallenge usually causes recurrence and should be avoided. There is no information on possible cross sensitivity to liver injury among various vasopressin 2 receptor antagonists, such as satavaptan, lixivaptan or conivaptan.

Drug Class: Diuretics, Vasopressin Antagonists

## CASE REPORTS

### Case 1. Acute hepatitis with jaundice attributed to tolvaptan therapy.(1,2)

A 45 year old woman with autosomal dominant polycystic kidney disease (ADPKD) developed mild symptoms of fatigue, abdominal pain, anorexia and nausea approximately 5 months after starting tolvaptan as a part of a controlled trial of this agent in ADPKD. She had no previous history of liver disease, alcohol use, or risk factors for viral hepatitis or drug allergies. Her liver tests had been normal before treatment and again 4 months after starting tolvaptan. Her other medical conditions included renal insufficiency, recurrent urinary tract infections, hypertension and osteoarthritis. Other medications included atenolol, impidapril and olmesartan, all of which she had taken chronically. Tolvaptan was continued and she was monitored more frequently. Tests for viral hepatitis and other causes of liver disease were said to be negative. Her symptoms improved for a few days, but then worsened as did serum enzyme abnormalities and serum bilirubin (Table). Tolvaptan was stopped approximately 6 weeks after onset of symptoms. Nevertheless, serum bilirubin levels continued to rise and peaked at 7.6 mg/dL 11 days after stopping tolvaptan. Subsequently, symptoms resolved and serum enzymes fell into the normal range within the next two months.

#### Key Points

Medication: | Tolvaptan (120 mg daily)
Pattern: | Hepatocellular (R=16.2)
Severity: | Moderate (hospitalized)
Latency: | 4 months
Recovery: | 2 months after stopping
Other medications: | Atenolol, impidapril, olmesartan

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 16 | | 14 | 0.4 | Tolvaptan started
123 days | Pre | 46 | 196 | 31 | 0.5
166 days | Pre | 570 | 358 | 274 | 0.5 | Symptomatic
177days | Pre | 332 | 262 | 246 | 0.5
190 days | Pre | 159 | 215 | 199 | 0.6
202 days | 0 | 882 | 338 | 323 | 1.4 | Tolvaptan stopped
207 days | 5 days | 809 | 316 | 244 | 4.1
213 days | 11 days | 598 | 325 | 206 | 7.6
222 days | 22 days | 200 | 240 | 189 | 2.0
232 days | 32 days | 57 | 170 | 124 | 1.8
249 days | 49 days | 30 | | 62 | 1.1
Normal Values | | <35 | <350 | <50 | <1.2

#### Comment

This patient developed symptoms and serum enzyme elevations 4 months after starting tolvaptan. The medication was continued and, after improving temporarily, she developed further symptoms and jaundice. No other cause of the abnormalities was found and all liver tests fell into the normal range within two months of stopping.

### Case 2. Acute hepatitis with jaundice attributed to tolvaptan therapy.(2,3)

A 44 year old woman with autosomal dominant polycystic kidney disease (ADPKD) participating in an experimental study of tolvaptan was found to have serum enzyme elevations at a routine 3 month study visit. She reported having mild and transient nausea and abdominal pain during the previous several weeks, but denied jaundice or dark urine. She had no previous history of liver disease or drug allergies. Her liver tests had been repeatedly normal in the past including during a three year period of taking placebo as a participant in a randomized controlled trial of tolvaptan. Tests were also normal just before starting open-label tolvaptan therapy (Table). She did not drink alcohol and had no risk factors for viral hepatitis. Her other medical conditions included renal insufficiency, recurrent urinary tract infections, hypertension and osteoarthritis. Other medications included perindopril, an antihypertensive, angiotensin converting enzyme (ACE) inhibitor available in Europe. Tolvaptan was stopped promptly, and she was admitted for evaluation and monitoring. During the ensuing weeks she developed more persistent symptoms of fatigue, nausea and anorexia followed by dark urine and jaundice. Tests for hepatitis A, B, C and E and mononucleosis were negative as were antinuclear and smooth muscle antibodies. Abdominal ultrasound and magnetic resonance imaging demonstrated multiple kidney and hepatic cysts, but no evidence of biliary obstruction or hepatic masses. A liver biopsy showed a cholestatic hepatitis with focal necrosis consistent with drug induced liver injury. In follow up, her symptoms resolved and liver tests were improved when she was seen 3 months after initial onset. During long term follow up, however, she continued to have mild elevations in serum aminotransferase levels (< twice ULN).

#### Key Points

Medication: | Tolvaptan (120 mg daily)
Pattern: | Hepatocellular (R=~15, using GGT)
Severity: | Moderate (hospitalized)
Latency: | 3 months
Recovery: | 3 months
Other medications: | Perindopril

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 12 | 16 | 0.4 | Tolvaptan started
89 days | 0 | 1243 | 122 | 0.8 | Tolvaptan stopped
98 days | 8 days | 1098 | 190 | 1.2 | Symptomatic
108 days | 18 days | 1742 | 208 | 9.6
4 months | 1 month | 746 | 164 | 10.2 | Liver biopsy
6 months | 3 months | 59 | 63 | 0.6
7 months | 4 months | 59 | 54 | 0.6
Normal Values | | <35 | <50 | <1.2

#### Comment

This patient developed a moderately severe acute hepatitis 90 days after starting tolvaptan in an experimental, open-label, rollover trial of this agent given long term in patients with symptomatic autosomal dominant polycystic kidney disease. The injury was detected during a routine visit and tolvaptan was promptly stopped. However, she developed symptoms and jaundice over the ensuing weeks with serum bilirubin rising to a peak of 10.2 mg/dL. A liver biopsy showed a cholestatic hepatitis without extensive necrosis. She was symptomatic for several weeks but eventually recovered, although she continued to have mild serum ALT and AST elevations in subsequent follow up. This was one of three cases of acute liver injury with jaundice that arose during the clinical development of tolvaptan as therapy for ADPKD.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tolvaptan – Jynarque®, Samsca®

DRUG CLASS

Diuretics, Vasopressin Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tolvaptan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tolvaptan | 150683-30-0 | C26-H25-Cl-N2-O3

## CITED REFERENCES

1 Clinical review. Tolvaptan; NDA 204441: Case 04251-731-2738
2 Watkins PB, Lewis JH, Kaplowitz N, Alpers DH, Blais JD, Smotzer DM, Krasa H, et al. (2015). Clinical pattern of tolvaptan-associated liver injury in subjects with autosomal dominant polycystic kidney disease: analysis of clinical trials database. Drug Saf.
3 Clinical review. Tolvaptan; NDA 204441: Case 08271-468-4301

## ANNOTATED BIBLIOGRAPHY

References updated: 02 September 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999 before the availability of tolvaptan or conivaptan).
Jackson EK. Drugs affecting renal excretory function. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 466-9. (Textbook of pharmacology and therapeutics; arginine vasopressin 2 receptors antagonists are aquaretics and nonpeptide inhibitors include conivaptan, tolvaptan, lixivaptan and mozavaptan).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/204441Orig1s000MedR.pdf [Medical Review: 230-257; 259-267] (FDA analysis of hepatotoxicity identified in the registration trials of tolvaptan for polycystic liver disease).
Schrier RW, Gross P, Gheorghiade M, Berl T, Verbalis JG, Czerwiec FS, Orlandi C. (2006). SALT Investigators. Tolvaptan, a selective oral vasopressin V2-receptor antagonist, for hyponatremia. N Engl J Med. (Summary of two controlled trials of 30 day courses of tolvaptan in 448 patients with hyponatremia due to SIADH, heart failure or cirrhosis found significant rise in serum sodium [6.2 vs 1.8 mmol/L], but few side effects except for thirst and dry mouth; with no reports of liver adverse events in tolvaptan treated patients).
Konstam MA, Gheorghiade M, Burnett JC, Grinfeld L, Maggioni AP, Swedberg K, Udelson JE, et al., Efficacy of Vasopressin Antagonism in Heart Failure Outcome Study With Tolvaptan (EVEREST) Investigators. (2007). Effects of oral tolvaptan in patients hospitalized for worsening heart failure: the EVEREST Outcome Trial. JAMA. (Controlled trial of tolvaptan [15 mg daily] vs placebo for 60 days in 4133 patients hospitalized for worsening heart failure found no effect of treatment on long term mortality; discussion and lists of side effects did not include ALT or AST elevations or clinically apparent liver injury).
Ginès P. (2007). Vaptans: a promising therapy in the management of advanced cirrhosis. J Hepatol. (Discussion of publication by Schrier [2006] mentioning the need for separate analysis and future studies of patients with hyponatremia due to cirrhosis as efficacy and safety may be different in this subgroup).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to tolvaptan or conivaptan).
(2009). Tolvaptan (Samsca) for hyponatremia. Med Lett Drugs Ther. (Concise review of the mechanism of action, efficacy and safety of tolvaptan shortly after its approval in the US does not mention ALT elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to tolvaptan or conivaptan).
Nemerovski C, Hutchinson DJ. (2010). Treatment of hypervolemic or euvolemic hyponatremia associated with heart failure, cirrhosis, or the syndrome of inappropriate antidiuretic hormone with tolvaptan: a clinical review. Clin Ther. (Review of the mechanism of action, efficacy and safety of tolvaptan; no mention of hepatotoxicity).
Okita K, Sakaida I, Okada M, Kaneko A, Chayama K, Kato M, Sata M, et al. (2010). A multicenter, open-label, dose-ranging study to exploratively evaluate the efficacy, safety, and dose-response of tolvaptan in patients with decompensated liver cirrhosis. J Gastroenterol. (Among 18 patients with cirrhosis and intractable ascites in whom tolvaptan was added to stable doses of diuretics, esophageal varices arose in 2 and encephalopathy in 1 patient; no mention of changes in routine liver test results).
Boyer TD. (2010). Tolvaptan and hyponatremia in a patient with cirrhosis. Hepatology. (Discussion of the pathophysiology of fluid overload and hyponatremia in cirrhosis [with clinical case example] and possible role and safety of tolvaptan; in controlled trials, gastrointestinal bleeding occurred in 10% of tolvaptan- vs 2% of placebo-treated patients).
Matsuzaki M, Hori M, Izumi T, Asanoi H, Tsutamoto T. (2011). Tolvaptan Investigators. Effects of tolvaptan on volume overload in Japanese patients with heart failure: results of a phase II, multicenter, randomized, double-blind, placebo-controlled, parallel-group study. Cardiovasc Drugs Ther. (In a controlled trial of tolvaptan [15, 30 or 45 mg once daily] vs placebo for 7 days in 117 patients with heart failure and fluid overload, tolvaptan was not associated with any major clinical concerns and was "clinically tolerable at all doses tested").
Matsuzaki M, Hori M, Izumi T, Fukunami M. (2011). Tolvaptan Investigators. Efficacy and safety of tolvaptan in heart failure patients with volume overload despite the standard treatment with conventional diuretics: a phase III, randomized, double-blind, placebo-controlled study(QUEST study). Cardiovasc Drugs Ther. (Controlled trial of tolvaptan [15 mg daily] vs placebo for 7 days in 110 patients with heart failure and fluid overload; side effects included thirst, constipation, urinary frequency and fatigue; ALT elevations and clinically apparent liver injury were not mentioned).
Fukunami M, Matsuzaki M, Hori M, Izumi T. (2011). Tolvaptan Investigators. Efficacy and safety of tolvaptan in heart failure patients with sustained volume overload despite the use of conventional diuretics: a phase III open-label study. Cardiovasc Drugs Ther. (Among 51 patients with congestive heart failure and fluid overload treated with tolvaptan for 7-14 days, ALT levels were increased in 6%, but no patient had a serious liver related adverse event).
Cabello Muriel A, Marín Pozo JF, Alcalá Sanz A, Carrillo Ortiz D. (2011). Hepatic alteration after treatment using tolvaptan. Farm Hosp. (75 year old man with lung cancer and symptomatic hyponatremia [sodium 120-128 mEq/L] due to SIADH developed liver test abnormalities 24 days after starting tolvaptan [ALT 378 U/L, GGT 3585 U/L, bilirubin and Alk P not given], which improved on stopping, but with limited follow up, as he died soon thereafter).
Higashihara E, Torres VE, Chapman AB, Grantham JJ, Bae K, Watnick TJ, Horie S, et al., TEMPO Formula and 156-05-002 Study Investigators. (2011). Tolvaptan in autosomal dominant polycystic kidney disease: three years' experience. Clin J Am Soc Nephrol. (Analysis of two 3-year studies of tolvaptan in 63 patients with polycystic kidney disease; ALT elevations occurred in 2 patients [3.2%]; no details given).
Torres VE, Chapman AB, Devuyst O, Gansevoort RT, Grantham JJ, Higashihara E, Perrone RD, et al. (2012). TEMPO 3:4 Trial Investigators. Tolvaptan in patients with autosomal dominant polycystic kidney disease. N Engl J Med. (Controlled trial of tolvaptan [up to 120 mg daily] vs placebo for 3 years in 1445 adults with polycystic kidney disease reported less increase in kidney cyst size and less decrease in renal function with tolvaptan; ALT elevations >2.5 times ULN occurred in 4.9% on tolvaptan vs 1.2% on placebo and 2 patients developed ALT elevations with jaundice, but no patient died and "the abnormalities either resolved during treatment or returned towards baseline values with drug interruption or withdrawal").
Wüthrich RP, Mei C. (2012). Aquaretic treatment in polycystic kidney disease. N Engl J Med. (Editorial in response to Torres [2012]).
Dahl E, Gluud LL, Kimer N, Krag A. (2012). Meta-analysis: the safety and efficacy of vaptans (tolvaptan, satavaptan and lixivaptan) in cirrhosis with ascites or hyponatraemia. Aliment Pharmacol Ther. (Systematic review of vaptans identified 12 controlled trials in a total of 2266 patients with cirrhosis and ascites; therapy had no effect on mortality or rates of variceal hemorrhage; no mention of ALT elevations or other liver complications).
Gaglio P, Marfo K, Chiodo J. (2012). Hyponatremia in cirrhosis and end-stage liver disease: treatment with the vasopressin V.-receptor antagonist tolvaptan. Dig Dis Sci. (Review of frequency, clinical features and complications of hyponatremia in cirrhosis and the possible role of tolvaptan in its management).
Ambrosy AP, Vaduganathan M, Huffman MD, Khan S, Kwasny MJ, Fought AJ, Maggioni AP, et al. (2012). EVEREST trial investigators. Clinical course and predictive value of liver function tests in patients hospitalized for worsening heart failure with reduced ejection fraction: an analysis of the EVEREST trial. Eur J Heart Fail. (Analysis of 2061 patients with heart failure enrolled in placebo arm of tolvaptan trials found that liver test abnormalities were frequent with ALT elevations in 21%, Alk P in 23% and bilirubin in 26%, but most elevations were mild and improved with therapy of heart failure).
Sakaida I, Yanase M, Kobayashi Y, Yasutake T, Okada M, Okita K. (2012). The pharmacokinetics and pharmacodynamics of tolvaptan in patients with liver cirrhosis with insufficient response to conventional diuretics: a multicentre, double-blind, parallel-group, phase III study. J Int Med Res. (Among 40 patients with cirrhosis and intractable ascites treated with tolvaptan [3.75 or 7.5 mg daily for 7 days], adverse events included hepatic encephalopathy in 4 [10%], but no specifics given).
Cho C, Logan JL, Lien YH. (2012). Massive aquaresis after tolvaptan administration and albumin infusion in a patient with alcoholic cirrhosis. Am J Med. (40 year old man with cirrhosis and hypervolemic hyponatremia had marked transient diuresis [from <50 to 800 mL/hr] after a single dose of tolvaptan, paracentesis and albumin infusions).
Cárdenas A, Ginès P, Marotta P, Czerwiec F, Oyuang J, Guevara M, Afdhal NH. (2012). Tolvaptan, an oral vasopressin antagonist, in the treatment of hyponatremia in cirrhosis. J Hepatol. (Subanalysis of trials reported by Schrier [2006] limited to patients with cirrhosis treated with tolvaptan [n=63] vs placebo [n=57] for 30 days; serious liver related adverse events occurred in 3 and deaths from liver disease in 2 tolvaptan treated subjects; gastrointestinal bleeding occurred in 6 [10%] tolvaptan- vs 1 [2%] placebo-treated patients).
Sakaida I, Kawazoe S, Kajimura K, Saito T, Okuse C, Takaguchi K, Okada M, et al., ASCITES-DOUBLEBLIND Study Group. (2014). Tolvaptan for improvement of hepatic edema: A phase 3, multicenter, randomized, double-blind, placebo-controlled trial. Hepatol Res. (Controlled trial of 7 days of tolvaptan vs placebo in 162 patients with cirrhosis and ascites found slight increase in serum sodium [1.2 vs -0.7] and decrease in body weight [-1.9 vs-0.4 kg] and ascites with tolvaptan therapy; "No marked abnormalities were clinically observed in clinical laboratory tests").
Yu C, Sharma N, Saab S. (2013). Hyponatremia: clinical associations, prognosis, and treatment in cirrhosis. Exp Clin Transplant. (Review of the management of hyponatremia in cirrhosis states that the effect of vaptans is dose dependent, starts 1-2 hours after administration, lasts for 4-12 hours, and is lost within a week of withdrawal, suggesting that continuous or long term therapy is needed).
Abhyankar A, Robson SC, Tapper EB, Bonder A. (2013). Letter in response to the recently published review: hyponatremia in cirrhosis and end-stage liver disease-treatment with the vasopressin v2-receptor antagonist tolvaptan. Dig Dis Sci. (Summary of experience in treating 9 patients with cirrhosis and hyponatremia using oral tolvaptan for periods ranging from 9 days to 2 years; the major "patient issues" were intense thirst and high cost; no mention of liver related side effects).
Yakushijin K, Yamamoto K, Kurata K, Miyata Y, Kakiuchi S, Tomioka H, Kawamori-Iwamoto Y, et al. (2013). Tolvaptan as an alternative treatment for refractory fluid retention associated with sinusoidal obstruction syndrome after allogeneic stem cell transplantation. Int J Hematol. (42 year old man with lymphoma developed sinusoidal obstruction syndrome 3 weeks after allogenic hematopoietic cell transplantation [with myeloablation with busulfan and cyclophosphamide] and was given two days of tolvaptan for ascites and fluid overload followed by rise of serum sodium to 159 mEq/L; patient ultimately died of hepatic and multiorgan failure).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to tolvaptan).
Watkins PB, Lewis JH, Kaplowitz N, Alpers DH, Blais JD, Smotzer DM, Krasa H, et al. (2015). Clinical pattern of tolvaptan-associated liver injury in subjects with autosomal dominant polycystic kidney disease: analysis of clinical trials database. Drug Saf. (Among 1445 patients with autosomal dominant polycystic kidney disease treated with tolvaptan or placebo, 4.4% receiving tolvaptan vs 1% receiving placebo developed ALT elevations above 3 times ULN, between 3-18 months after starting and resolving in all; 2 developing jaundice and symptoms [as did another who was crossed over from placebo to tolvaptan: cases 1 and 2]; similar episodes were not seen in the 2250 subjects treated with tolvaptan for hyponatremia; Cases 1 and 2).
Mosedale M, Kim Y, Brock WJ, Roth SE, Wiltshire T, Eaddy JS, Keele GR, et al. (2017). Editor's Highlight: Candidate risk factors and mechanisms for tolvaptan-Induced liver injury are identified using a collaborative cross approach. Toxicol Sci. (Screening of mouse strains that develop ALT elevations in response to tolvaptan found that genes of bile acid homeostasis as well as oxidative stress and immune response were activated by exposure to the drug).
Muto S, Okada T, Yasuda M, Tsubouchi H, Nakajima K, Horie S. (2017). Long-term safety profile of tolvaptan in autosomal dominant polycystic kidney disease patients: TEMPO Extension Japan Trial. Drug Healthc Patient Saf. (Among 135 Japanese patients with autosomal dominant polycystic kidney disease enrolled in an open label extension trial of tolvaptan for up to 3 years, 5.9% developed ALT elevations above 3 times ULN, but none had concurrent symptoms or jaundice and all resolved spontaneously or with dose interruption).
Makabe S, Mochizuki T, Mitobe M, Aoyama Y, Kataoka H, Tsuchiya K, Nitta K. (2018). Elevation of the serum liver enzyme levels during tolvaptan treatment in patients with autosomal dominant polycystic kidney disease (ADPKD). Clin Exp Nephrol. (Among 63 Japanese patients with autosomal dominant polycystic kidney disease treated with tolvaptan, 7 developed ALT elevations between months 2 and 8 [ALT 37 to 77 U/L] and tolvaptan was stopped, but was subsequently restarted in 6 whose ALT levels rapidly improved of whom only one had any recurrence of enzyme elevations; in one subject ALT levels increased after topping tolvaptan to a peak of 980 U/L and drug was not restarted; none developed bilirubin elevations or symptoms).
Khan MY, Rawala MS, Siddiqui M, Abid W, Aslam A. (2019). Tolvaptan-induced liver injury: who is at risk? a case report and literature review. Cureus. (86 year old woman with inappropriate antidiuretic hormone syndrome and hyponatremia [118 mmoL/L] was found to have liver test abnormalities the day after starting tolvaptan [bilirubin 2.8 mg/dL, ALT 193 U/L, Alk P 424 U/L], which rose over the next several days despite stopping tolvaptan and were still elevated when last seen 7 days later [bilirubin 5.5 mg/dL, ALT 164 U/L, Alk P 815 U/L] with no further information on the course of illness).
Endo M, Katayama K, Matsuo H, Horiike S, Nomura S, Hayashi A, Ishikawa E, et al. (2019). Role of liver transplantation in tolvaptan-associated acute liver failure. Kidney Int Rep. (36 year old Japanese woman with autosomal dominant polycystic kidney disease developed abnormal ALT levels 5 months after starting tolvaptan that continued to rise despite dose modification and discontinuation [bilirubin 5.2 mg/dL, ALT 426 U/L, Alk P 305 U/L, INR 2.8], with progressive hepatic failure leading to liver transplantation).
Pellegrino AM, Annicchiarico Petruzzelli L, Riccio E, Pisani A. (2019). Idiosyncratic hepatic toxicity in autosomal dominant polycystic kidney disease (ADPKD) patient in combined treatment with tolvaptan and amoxicillin/clavulanic acid: a case report. BMC Nephrol. (41 year old woman with autosomal dominant polycystic kidney disease developed ALT elevations at week 12 of therapy with tolvaptan and 5 weeks after receiving a course of amoxicillin-clavulanate, which continued to worsen to an ALT peak of 808 U/L, eventually falling into the normal range by week 24; no mention of bilirubin or Alk P levels).
Sakaida I, Terai S, Kurosaki M, Okada M, Hirano T, Fukuta Y. (2020). Real-world effectiveness and safety of tolvaptan in liver cirrhosis patients with hepatic edema: results from a post-marketing surveillance study (START study). J Gastroenterol. (In postmarketing studies on the safety of tolvaptan in 1,111 Japanese patients with cirrhosis who were treated with a mean daily dose of 6 mg for an average of 82 days, side effects included thirst [6.6%], hepatic encephalopathy [2.3%], dehydration [1.5%] and hypernatremia [1.5%] and there were 157 deaths, 15 of which were considered possibly related to tolvaptan).
Raina R, Chakraborty R, DeCoy ME, Kline T. (2020). Autosomal-dominant polycystic kidney disease: tolvaptan use in adolescents and young adults with rapid progression. Pediatr Res. (Among 52 young adults [ages 18 to 24 years] enrolled in the TEMPO 3:4 Trial which compared tolvaptan to placebo in patients with autosomal dominant polycystic kidney disease, clinical response rates were similar in younger vs older subjects, but none of the young subjects developed serum ALT elevations during therapy compare to 4% of the older adults).

## OTHER REFERENCE LINKS

1 Recent References on Tolvaptan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tolvaptan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tolvaptan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tolvaptan)